# Idelalisib

## OVERVIEW

### Introduction

Idelalisib is an oral kinase inhibitor that is approved for use in combination with rituximab in relapsed or refractory chronic lymphocytic leukemia (CLL) and as monotherapy for relapsed follicular B cell, small lymphocytic lymphoma and indolent non-Hodgkin lymphoma. Idelalisib is associated with a high rate of serum enzyme elevations during therapy and has been reported to cause clinically apparent acute liver injury that can be severe and even fatal.

### Background

Idelalisib (eye del" a lis' ib) is an orally available, small molecule inhibitor of phosphatidylinositol 3-kinase delta (PI3Kδ), which is an essential component in the B cell signaling pathways that drive migration of B cells to lymph nodes and bone marrow. Inhibition of this pathway inhibits B cell chemotaxis and adherence and reduces cell viability. This pathway is upregulated in many B cell malignancies and has been shown to be critical for proliferation and survival of leukemia and lymphomatous malignant B lymphocytes. Idelalisib was approved for use in the United States as therapy for relapsed CLL in combination with rituximab and as monotherapy for indolent forms of non-Hodgkin’s lymphoma in 2014. It is not recommended as a first-line therapy of leukemias or lymphomas. Idelalisib is available as tablets of 100 and 150 mg under the brand name Zydelig. The recommended dose is 150 mg twice daily until disease progression or unacceptable toxicity. Side effects are common but usually mild-to-moderate in severity, and include nausea, diarrhea, headache, stomatitis, fever, pain, rash, infections, arthralgia and fatigue. Common laboratory abnormalities can include cytopenias, liver enzyme elevations, hyper- or hypo-glycemia, and hyponatremia. Severe adverse events (for which it has a black box warning) can include liver failure, severe diarrhea, pneumonitis, intestinal perforation, severe skin rash, anaphylaxis, neutropenia and embryo-fetal toxicity.

### Hepatotoxicity

In clinical trials of idelalisib combined with rituximab in patients with CLL and lymphoma, the rates of serum enzyme elevations during therapy ranged from 25% to 35% and were above 5 times the ULN in 5% to 8% (compared to 1% with placebo and rituximab). Severe instances of severe acute hepatocellular injury and acute liver failure were reported in patients receiving idelalisib alone and with rituximab, but the clinical features of the cases were not be described in detail. Serum enzyme elevations typically arose within 4 to 12 weeks of starting therapy and usually resolved rapidly with temporary discontinuation. In some instances, however, serum aminotransferases remained high despite stopping therapy, and in this situation corticosteroids appeared to have a beneficial effect. Most patients who developed significant serum enzyme elevations with idelalisib had a rapid recurrence upon rechallenge. In patients receiving corticosteroids, however, recurrence was less common and generally mild, allowing for restarting of therapy in many patients. Thus, idelalisib is a frequent cause of acute hepatocellular injury which may have an autoimmune component. Because of its many serious adverse events and limited efficacy in comparison to other agents, idelalisib has not been widely used and it potential for causing acute clinically apparent liver injury with jaundice has not been well defined.

Because, idelalisib affects B cell function, it may also be capable of inducing reactivation of hepatitis B, although in published trials of the agent, reactivation was not reported.

Likelihood score: D (possible cause of clinically apparent liver injury).

### Mechanism of Injury

The reason why idelalisib causes serum enzyme elevations is not known, but may be a direct toxicity to hepatocytes caused by inhibition of PI3K activity or the result of change in B cell activity and caused by induction of autoimmunity. Idelalisib is metabolized primarily by aldehyde oxidase which is present in many tissues, but highest concentrations are in the liver. The cytochrome P450 system plays a minor role in the metabolism (CYP 3A4) of idelalisib, but concentrations may be affected by drugs that induce or inhibit CYP 3A activity.

### Outcome and Management

Serum enzyme elevations are not uncommon during cancer chemotherapy with idelalisib and may be dose limiting. Idelalisib should not be used with other agents with hepatotoxic potential. Furthermore, regular monitoring of liver tests every 2 to 4 weeks is recommended during the first six months of idelalisib therapy and every 1 to 3 months thereafter, with more frequent monitoring if serum aminotransferase values rise. Idelalisib should be held if ALT or AST values rise above 5 times the ULN, and treatment resumed only if and when values fall into the normal range and then with a reduced dose and careful monitoring. Elevations of aminotransferase values of more than 20 times the ULN, or appearance of jaundice or symptoms of liver injury should trigger permanent discontinuation. Corticosteroids are often used if the liver injury does not resolve rapidly with stopping idelalisib, and continuing the corticosteroids may help prevent recurrence of injury with restarting therapy. There is no known cross sensitivity to hepatic injury among the different protein kinase inhibitors.

Drug Class: Antineoplastic Agents, Protein Kinase Inhibitors

## PRODUCT INFORMATION

REPRESENTATIVE TRADE NAMES

Idelalisib – Zydelig®

DRUG CLASS

Antineoplastic Agents

COMPLETE LABELING (https://dailymed.nlm.nih.gov/dailymed/search.cfm?labeltype=all&query=Idelalisib)

Product labeling at DailyMed, National Library of Medicine, NIH

## CHEMICAL FORMULA AND STRUCTURE

DRUG | CAS REGISTRY NO | MOLECULAR FORMULA | STRUCTURE
Idelalisib | 870281-82-6 | C22-H18-F-N7-O

## ANNOTATED BIBLIOGRAPHY

References updated: 12 July 2022

Abbreviations: CLL, chronic lymphocytic leukemia; PI3K, phosphatidylinositol 3-kinase; SLL, small cell lymphocytic lymphoma.

Zimmerman HJ. Hepatotoxicity: the adverse effects of drugs and other chemicals on the liver. 2nd ed. Philadelphia: Lippincott, 1999. (Review of hepatotoxicity published in 1999 before the availability of tyrosine kinase receptor inhibitors).
DeLeve LD. Kinase inhibitors. Gefitinib. Cancer chemotherapy. In, Kaplowitz N, DeLeve LD, eds. Drug-induced liver disease. 3rd ed. Amsterdam: Elsevier, 2013, p. 556. (Review of hepatotoxicity of cancer chemotherapeutic agents; does not discuss idelalisib or other PI3K inhibitors).
Wellstein A, Giaccone G, Atkins MB, Sausville EA. Pathway-targeted therapies: monoclonal antibodies, protein kinase inhibitors, and various small molecules. In, Brunton LL, Hilal-Dandan R, Knollman BC, eds. Goodman & Gilman's the pharmacological basis of therapeutics. 13th ed. New York: McGraw-Hill, 2018, pp. 1203-36. (Textbook of pharmacology and therapeutics).
Furman RR, Sharman JP, Coutre SE, Cheson BD, Pagel JM, Hillmen P, Barrientos JC, et al. (2014). Idelalisib and rituximab in relapsed chronic lymphocytic leukemia. N Engl J Med. (Among 220 patients with relapsed CLL treated in a placebo controlled trial, progression-free survival improved with idelalisib and rituximab compared to rituximab alone, but side effects were more common with the combination including ALT or AST elevations [35% vs 19%], which were above 5 times ULN in 5% vs 1% and led to drug discontinuations in some patients, but there were no clinically apparent cases of liver injury).
Gopal AK, Kahl BS, de Vos S, Wagner-Johnston ND, Schuster SJ, Jurczak WJ, Flinn IW, et al. (2014). PI3Kδ inhibition by idelalisib in patients with relapsed indolent lymphoma. N Engl J Med. (Among 125 patients with refractory non-Hodgkin lymphoma, treatment with idelalisib yielded a 59% objective response rate, while side effects included diarrhea [43%], fatigue [30%], nausea [30%], cough [29%], fever [28%] and ALT elevations [13%] which led to discontinuations in 5 patients [4%]).
Kahl BS, Spurgeon SE, Furman RR, Flinn IW, Coutre SE, Brown JR, Benson DM, et al. (2014). A phase 1 study of the PI3Kδ inhibitor idelalisib in patients with relapsed/refractory mantle cell lymphoma (MCL). Blood. (Among 40 patients with refractory mantle cell lymphoma treated with idelalisib for 1-31 months, overall response rate was 40% and side effects were common, ALT or AST elevations occurred in 24 [60%] patients and were above 5 times ULN in 8 [20%], typically arising 4-9 weeks after starting and resolving rapidly upon stopping).
Coutré SE, Barrientos JC, Brown JR, de Vos S, Furman RR, Keating MJ, Li D, et al. (2015). Management of adverse events associated with idelalisib treatment: expert panel opinion. Leuk Lymphoma. (Expert opinion on management of adverse events from idelalisib therapy with major discussions of diarrhea, serum aminotransferase elevations and pneumonitis; recommends monitoring of liver tests and discontinuing therapy based upon FDA guidelines using the height of ALT or AST elevations over the upper limit of normal).
Jin F, Robeson M, Zhou H, Hisoire G, Ramanathan S. (2015). The pharmacokinetics and safety of idelalisib in subjects with moderate or severe hepatic impairment. J Clin Pharmacol. (Pharmacokinetic studies of single doses of idelalisib in patients with mild or moderate liver dysfunction found minor differences in drug or metabolite plasma concentrations or disappearance curves).
Horak F, Puri KD, Steiner BH, Holes L, Xing G, Zieglmayer P, Zieglmayer R, et al. (2016). Randomized phase 1 study of the phosphatidylinositol 3-kinase δ inhibitor idelalisib in patients with allergic rhinitis. J Allergy Clin Immunol. (Among 41 patients with allergic rhinitis treated with idelalisib or placebo for 7 days and then challenged with allergen, allergic symptoms were less in idelalisib treated subjects, none of whom had ALT elevations).
(2015). Idelalisib (Zydelig) for chronic lymphocytic leukemia and non-Hodgkins lymphoma. Med Lett Drugs Ther. (Concise review of mechanism of action, efficacy, safety and cost of idelalisib shortly after its approval for use in the US mentions that reported serious adverse events include fatal hepatotoxicity, diarrhea, colitis, pneumonitis and intestinal perforation).
Jin F, Robeson M, Zhou H, Hisoire G, Ramanathan S. (2015). The pharmacokinetics and safety of idelalisib in subjects with moderate or severe hepatic impairment. J Clin Pharmacol. (Single dose studies in patients with moderate and severe liver impairment [Child's Class B and C] found similar maximum plasma concentrations compared to healthy controls, suggesting that dose adjustment for liver disease is not necessary).
de Vos S, Wagner-Johnston ND, Coutre SE, Flinn IW, Schreeder MT, Fowler NH, Sharman JP, et al. (2016). Combinations of idelalisib with rituximab and/or bendamustine in patients with recurrent indolent non-Hodgkin lymphoma. Blood Adv. (In a trial of idelalisib combined with rituximab or bendamustine or both for a median of 10 months, response rates were 75-88%, but adverse events were frequent including ALT elevations [46%], 16% above 5 times ULN).
Lampson BL, Kasar SN, Matos TR, Morgan EA, Rassenti L, Davids MS, Fisher DC, et al. (2016). Idelalisib given front-line for treatment of chronic lymphocytic leukemia causes frequent immune-mediated hepatotoxicity. Blood. (Among 24 patients with relapsed or refractory CLL treated with idelalisib, 19 [79%] developed ALT elevations which were above 5 times ULN in 13 [54%], usually within 28 days of starting therapy and sometimes worsening despite drug discontinuation leading to corticosteroid therapy in 16 subjects; rechallenge with idelalisib led to recurrence within a few days, but abnormalities were mild and tolerable in those on corticosteroids).
Smith SM, Pitcher BN, Jung SH, Bartlett NL, Wagner-Johnston N, Park SI, Richards KL, et al. (2017). Safety and tolerability of idelalisib, lenalidomide, and rituximab in relapsed and refractory lymphoma: the Alliance for Clinical Trials in Oncology A051201 and A051202 phase 1 trials. Lancet Haematol. (A preliminary study with idelalisib combined with rituximab and lenalidomide in 11 patients with lymphoma was closed early because of severe adverse events including sepsis, severe rash, and ALT elevations above 20 times ULN in two subjects).
Jones JA, Robak T, Brown JR, Awan FT, Badoux X, Coutre S, Loscertales J, et al. (2017). Efficacy and safety of idelalisib in combination with ofatumumab for previously treated chronic lymphocytic leukaemia: an open-label, randomised phase 3 trial. Lancet Haematol. (Among 261 patients with refractory CLL treated with the ofatumumab with or without idelalisib, progression-free survival was higher with idelalisib [16 vs 8 months], but adverse events were also more frequent including severe infections and ALT elevations [53% vs 21%] which were above 5 times ULN in 11% vs 1% and which led to discontinuation of idelalisib in 4 patients [2%]; no deaths were attributed to hepatic failure).
Zelenetz AD, Barrientos JC, Brown JR, Coiffier B, Delgado J, Egyed M, Ghia P, et al. (2017). Idelalisib or placebo in combination with bendamustine and rituximab in patients with relapsed or refractory chronic lymphocytic leukaemia: interim results from a phase 3, randomised, double-blind, placebo-controlled trial. Lancet Oncol. (Among 416 patients with CLL treated with bendamustine and rituximab with or without idelalisib, progression-free survival was greater with idelalisib [20.8 vs 11.1 months] as were adverse events including febrile neutropenia [24% vs 5%], severe diarrhea [9% vs 2%], and ALT elevations above 5 times ULN [21% vs 3%], and one treatment related death was attributed to "liver disorder").
Coutre SE, Flinn IW, de Vos S, Barrientos JC, Schreeder MT, Wagner-Johnson ND, Sharman JP, et al. (2018). Idelalisib in combination with rituximab or bendamustine or both in patients with relapsed/refractory chronic lymphocytic leukemia. Hemasphere. (Among 52 patients with relapsed or refractory CLL treated with idelalisib [100 or 150 mg twice daily] with either bendamustine or rituximab or both, the overall response rate was 85% and significant adverse events were frequent [94%] including pneumonia [19%], febrile neutropenia [17%], diarrhea [14%], and ALT or AST elevations above 5 times ULN [5%]; among 8 deaths due to adverse events, none were liver related).
Sharman JP, Coutre SE, Furman RR, Cheson BD, Pagel JM, Hillmen P, Barrientos JC, et al. (2019). Final results of a randomized, phase III study of rituximab with or without idelalisib followed by open-label idelalisib in patients with relapsed chronic lymphocytic leukemia. J Clin Oncol. (Among 220 patients with relapsed CLL treated with rituximab and either idelalisib [150 mg twice daily] or placebo, overall survival was greater with idelalisib [41 vs 35 months], but significant adverse events were more frequent [74% vs 54%] including infections [33% vs 23%] and ALT elevations [39% vs 10%] and with values above 5 times ULN [9% vs 5%]).
Curigliano G, Shah RR. (2019). Safety and Tolerability of phosphatidylinositol-3-kinase (PI3K) inhibitors in oncology. Drug Saf. (Review of the safety of PI3K inhibitors which are associated with serious adverse events in up to 60% of patients, more commonly when given in combination with other antineoplastic agents, with both infectious and immune related events which can be severe and involve skin [Stevens Johnson syndrome], lung [pneumonitis], colon [colitis], and liver [usually aminotransferase elevations]).
Ghia P, Pluta A, Wach M, Lysak D, Kozak T, Simkovic M, Kaplan P, et al. (2020). ASCEND: phase III, randomized trial of acalabrutinib versus idelalisib plus rituximab or bendamustine plus rituximab in relapsed or refractory chronic lymphocytic leukemia. J Clin Oncol. (Among 310 patients with relapsed or refractory CLL treated with acalabrutinib vs idelalisib and rituximab with or without bendamustine, the 12 month predicted progression-free survival was 88% vs 68% and serious adverse event rates were 29% vs 56% and ALT elevations above 5 times ULN arose in 1% vs 6%).
Borazanci E, Pishvaian MJ, Nemunaitis J, Weekes C, Huang J, Rajakumaraswamy N. (2020). A phase Ib study of single-agent idelalisib followed by idelalisib in combination with chemotherapy in patients with metastatic pancreatic ductal adenocarcinoma. Oncologist. (An early phase trial of idelalisib in patients with metastatic pancreatic cancer was terminated after enrollment of only 16 patients because of concerns over safety, ALT elevations above 5 times ULN arising in 25%, frequently accompanied by rash).
Eyre TA, Preston G, Kagdi H, Islam A, Nicholson T, Smith HW, Cursley AP, et al. (2021). A retrospective observational study to evaluate the clinical outcomes and routine management of patients with chronic lymphocytic leukaemia treated with idelalisib and rituximab in the UK and Ireland (RETRO-idel). Br J Haematol. (Among 110 patients with CLL treated with idelalisib and rituximab analyzed in a retrospective study from the UK, the overall response rate was 88% but adverse events were common, led to discontinuation in 49%, and include pneumonia [10%], colitis [6%], neutropenic sepsis [4.5%], rash [3%] and ALT elevations [1%]).
Tomowiak C, Poulain S, Herbaux C, Perrot A, Mahé B, Morel P, Aurran T, et al. (2021). Obinutuzumab and idelalisib in symptomatic patients with relapsed/refractory Waldenström macroglobulinemia. Blood Adv. (Among 48 patients with relapsed or refractory Waldenstrӧm macroglobulinemia treated with idelalisib and obinutuzumab [anti-CD20] for 6 cycles followed by maintenance idelalisib, the overall response rate was 71%, although 21% of patients had dose reductions and 54% discontinued therapy early for side effects which included neutropenia [19%], infections [19%], diarrhea [9%] and “hepatic cytolysis [9%]).
Wagner-Johnston ND, Schuster SJ, deVos S, Salles G, Jurczak WJ, Flowers CR, Viardot A, et al. (2021). Outcomes of patients with up to 6 years of follow-up from a phase 2 study of idelalisib for relapsed indolent lymphomas. Leuk Lymphoma. (Long term follow up [6 years] of a phase 2 study of idelalisib for relapsed indolent lymphoma demonstrated that the adverse event profile changed, most ALT elevations arising during the initial 6 months of treatment, while diarrhea, nausea, fever and infections continued to occur: “idelalisib monotherapy may be a reasonable treatment option when standard therapies have been exhausted”).
Hoechstetter MA, Knauf W, Dambacher S, Hucke N, Höhne K, van Troostenburg A, Ramroth H, et al. (2022). Results of a prospective non-Interventional post-authorization safety study of idelalisib in Germany. Clin Lymphoma Myeloma Leuk. (Among 147 patients with CLL or follicular lymphoma treated with idelalisib in Germany between 2015 and 2020, the overall response rate among patients with CLL was 70% and with lymphoma was 36% while frequent adverse events were diarrhea, nausea, pneumonia, rash, and fatigue with ALT elevations above 5 times ULN in 3%).
Casadei B, Argnani L, Broccoli A, Patti C, Stefani PM, Cuneo A, Margiotta Casaluci G, et al. (2022). Treatment with idelalisib in patients with relapsed or refractory follicular lymphoma: the observational Italian multicenter FolIdela Study. Cancers (Basel). (Among 72 patients in a retrospective study of Italian patients with relapsed or refractory follicular lymphoma treated with idelalisib, the overall response rate was 42% and adverse event rate was 44% which included elevations in ALT or AST levels above 5 times ULN in 7%, but there were no liver related serious adverse events or deaths).

## OTHER REFERENCE LINKS

1 Recent References on Idelalisib: from PubMed.gov (https://www.ncbi.nlm.nih.gov/sites/entrez?cmd=search&db=pubmed&pubmedfilters=true&term=Idelalisib/AE+AND+Human%5BMH%5D+AND+(jaundice/CI+OR+bile+duct+diseases/CI+OR+liver/DE+OR+liver+diseases/CI+OR+hepatitis,+toxic%5BMH%5D))
2 Trials on Idelalisib: from ClinicalTrials.gov (https://clinicaltrials.gov/ct2/results?term=Idelalisib)